# Cyclophosphamide

## OVERVIEW

### Introduction

Cyclophosphamide is an alkylating agent used in the treatment of several forms of cancer including leukemias, lymphomas and breast cancer. Cyclophosphamide therapy is associated with minor transient serum enzyme elevations and has been linked to rare cases of acute liver injury. In addition, when given in high doses as a part of a myeloablative therapy, cyclophosphamide can cause acute sinusoidal obstruction syndrome.

### Background

Cyclophosphamide (sye" kloe fos' fa mide) is a synthetic, nitrogen mustard-like alkylating agent that is widely used in the therapy of cancer and in severe forms of autoimmune disease. It requires activation in the liver to form its active intermediaries which act by modifying and cross linking purine bases in DNA, thus inhibiting DNA, RNA and protein synthesis and causing cell death in rapidly dividing cells. Cyclophosphamide was approved for use in the United States in 1959 and its current indications include treatment of breast, head, neck, lung, cervix, testis and ovarian cancer, acute and chronic lymphocytic leukemia, Hodgkin's and non-Hodgkin’s lymphoma, malignant histiocytosis, multiple myeloma, soft tissue sarcoma, mycosis fungoides, neuroblastoma, and retinoblastoma. Cyclophosphamide is also used in severe autoimmune disorders including minimal change nephrotic syndrome not responsive to conventional therapy. Cyclophosphamide is also occasionally used in the prevention of rejection after organ transplantation. Cyclophosphamide is available as tablets or capsules of 25 and 50 mg and as a powder or in liquid solution for intravenous use in generic forms and under the trade name Cytoxan. The recommended dosage varies from 1 to 5 mg/kg per day with the patient age, body weight, mode of administration and disease entity. Common side effects of include alopecia, nausea, vomiting, diarrhea, gastrointestinal upset, cystitis, oral ulcers and bone marrow suppression. Rare, but potentially severe adverse events include severe neutropenia, sepsis, cardiotoxicity, hemorrhagic cystitis, embryo-fetal toxicity and secondary malignancies.

### Hepatotoxicity

Mild and transient elevations in serum aminotransferase levels are found in up to 43% of patients with cancer who are treated with cyclophosphamide. The abnormalities are generally asymptomatic and transient and do not require dose modification. Enzyme elevations are more common with higher doses and with intravenous therapy. In some instances, marked elevations arise warranting dose modification or discontinuation of cyclophosphamide (Case 3).

Clinically apparent liver injury from standard doses of cyclophosphamide is uncommon, but several case reports of acute liver injury with jaundice have been published (Cases 1 and 2). The onset is within 2 to 8 weeks of starting cyclophosphamide and the pattern of serum enzyme elevations is hepatocellular. Immunoallergic and autoimmune features are uncommon. The injury in most cases is self-limited and resolves within 1 to 3 months of stopping; however, fatal instances have been reported. Recurrence on reexposure has been described.

High doses of cyclophosphamide given as chemotherapy of cancer or as myeloablative therapy in combination of total body irradiation or busulfan in preparation for hematopoietic cell transplantation can induce sinusoidal obstruction syndrome (veno-occlusive disease), which can be severe leading to acute liver failure and death. The onset of injury is usually within 10 to 20 days of the myeloablation and is characterized by a sudden onset of abdominal pain, weight gain, ascites, marked increase in serum aminotransferase levels (and lactic dehydrogenase), and subsequent jaundice and hepatic dysfunction. The severity of sinusoidal obstruction syndrome varies from a transient, self limited injury to acute liver failure. The diagnosis is usually based on clinical features of tenderness and enlargement of the liver, weight gain, ascites and jaundice. Liver biopsy is diagnostic but often contraindicated, because of severe thrombocytopenia after hematopoietic cell transplantation.

Likelihood score: B (highly likely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of idiosyncratic hepatotoxicity from cyclophosphamide is not known. The sinusoidal obstruction syndrome induced by cyclophosphamide is probably related to the direct toxic effect of cyclophosphamide on sinusoidal cells in the liver, causing their necrosis and release into the sinusoids, obstruction and obliteration of hepatic veins. Cyclophosphamide is extensively metabolized by hepatic cytochrome P450 system and more than 150 metabolites have been identified, but their pharmacokinetics and toxicities are not well defined.

### Outcome and Management

The severity of liver injury attributed to cyclophosphamide ranges from mild elevations in liver enzymes to acute liver injury or to massive, fatal hepatic necrosis due to sinusoidal obstruction syndrome. There is currently no specific therapy for the idiosyncratic liver injury due to cyclophosphamide or for veno-occlusive disease other than supportive management and avoidance of further damage. Defibrotide is currently approved for use in treating severe sinusoidal obstruction syndrome accompanied by renal or pulmonary failure occurring after myeloablative therapy in preparation for hematopoietic cell transplantation, but its efficacy has not been well documented. Rechallenge after recovery from clinically apparent liver injury attributed to cyclophosphamide should be avoided. Whether there is cross reactivity to the hepatic injury with other alkylating agents is not known.

Drug Class: Antineoplastic Agents, Alkylating Agents

## CASE REPORTS

### Case 1. Acute liver injury with jaundice during cyclophosphamide therapy.

[Modified from: Akay H, Akay T, Secilmis S, Kocak Z, Donderici O. Hepatotoxicity after low-dose cyclophosphamide therapy. South Med J 2006; 99: 1399-400. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/17233202)]

A 40 year old male with scleroderma developed jaundice 6 weeks after starting oral cyclophosphamide (100 mg daily) and low doses of corticosteroids. He had no history of liver disease, alcohol abuse of risk factors for viral hepatitis. He was taking no other medications. He had been treated with d-penicillamine for his scleroderma without complications several years earlier. Laboratory findings included serum bilirubin of 10.5 mg/dL (direct 6.3 mg/dL) with markedly elevated ALT (2407 U/L) and AST (1806 U/L) levels and modest increases in alkaline phosphatase (206 U/L) and GGT (202 U/L) levels. Tests for hepatitis A, B and C were negative as were autoantibodies. Ultrasound of the abdomen showed no evidence of biliary obstruction. Cyclophosphamide was discontinued and his symptoms and laboratory tests improved. All liver tests were normal when tested 3 months later.

#### Key Points

Medication: | Cyclophosphamide (100 mg daily)
Pattern: | Hepatocellular (R=33)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 6 weeks
Recovery: | 11 weeks
Other medications: | Corticosteroids

#### Comment

This patient developed an acute viral hepatitis-like syndrome 6 weeks after starting cyclophosphamide for an autoimmune condition. The relationship to cyclophosphamide therapy is suggestive but not proven, particularly because of the possibility of viral hepatitis with unusual serology such as hepatitis C with delay in production of anti-HCV or an unusual form of hepatitis, such as hepatitis E. Nevertheless, cyclophosphamide induced idiosyncratic liver disease typically arises within 2 to 8 weeks of starting therapy and usually has a hepatocellular pattern of serum enzyme elevations.

### Case 2. Acute liver injury with jaundice during cyclophosphamide therapy.

[Modified from: Cleland BD, Pokorny CS. Cyclophosphamide related hepatotoxicity. Aust N Z J Med 1993; 23: 408. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/8240157)]

A 67 year old woman developed nausea and dark urine 8 weeks after starting oral cyclophosphamide (100 mg daily) for nephrotic syndrome thought to be due to lupus erythematosus. She had a history of acute hepatitis as a child and had received a blood transfusion one year previously. However, she had no known chronic liver disease or alcohol abuse and liver tests had been normal before cyclophosphamide was started. Her other medications included prednisone 10 mg daily, insulin and thyroxine. On examination, she was jaundiced but had no hepatosplenomegaly or abdominal tenderness, rash or fever. Laboratory tests showed serum bilirubin of 9.2 mg/dL, ALT 2515 U/L, GGT 525 U/L, and alkaline phosphatase 456 U/L, with blood counts showing 14% eosinophils. The prothrombin time was normal. Tests for hepatitis A and C were negative and she had serological evidence of previous hepatitis B (anti-HBs and anti-HBc, but no HBsAg). Cyclophosphamide was discontinued and her liver test abnormalities improved rapidly. Four weeks later, serum bilirubin was 0.6 mg/dL, ALT 24 U/L and alkaline phosphatase 63 U/L. She did not undergo liver biopsy or rechallenge with cyclophosphamide.

#### Key Points

Medication: | Cyclophosphamide (100 mg daily)
Pattern: | Hepatocellular (R=16.5)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 8 weeks
Recovery: | 4 weeks
Other medications: | Corticosteroids, insulin, thyroxine

#### Comment

This patient developed an acute liver injury with jaundice 8 weeks after starting cyclophosphamide for an autoimmune condition. The pattern of serum enzyme elevations was hepatocellular, but the alkaline phosphatase and GGT levels were somewhat more elevated than typically occurs in viral hepatitis. The presence of eosinophilia also suggested a drug reaction. Without rechallenge, the role of cyclophosphamide in this hepatic injury cannot be considered definitely proven. Another possibility is that she had a relapsing autoimmune hepatitis associated with her lupus nephritis. However, the timing of onset and hepatocellular pattern of serum enzyme elevations fits well with other reports of idiosyncratic, cyclophosphamide induced liver injury.

### Case 3. Acute anicteric liver injury during cyclophosphamide therapy.

[Modified from: Snyder LS, Heigh RI, Anderson ML. Cyclophosphamide induced hepatotoxicity in a patient with Wegener’s granulomatosis. Mayo Clin Proc 1993; 68: 1203-4. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/8246624)]

A 67 year old woman was found to have abnormal liver test results 5 weeks after starting cyclophosphamide for Wegener’s granulomatosis. She was asymptomatic and denied a history of liver disease, alcohol abuse or risk factors for viral hepatitis. Her only other medication was prednisone (30 mg every other day). Her serum enzymes had been normal in the past, before cyclophosphamide therapy. Laboratory tests showed marked elevations in both serum aminotransferase and alkaline phosphatase levels, but normal serum bilirubin and prothrombin time (Table). Cyclophosphamide was stopped and she rapidly improved. All tests were normal 7 weeks after the medication was stopped.

#### Key Points

Medication: | Cyclophosphamide (100 mg daily)
Pattern: | Hepatocellular-mixed (R=5.2)
Severity: | 1+ (liver enzyme elevations without jaundice or symptoms)
Latency: | 5 weeks
Recovery: | 7 weeks
Other medications: | Corticosteroids, insulin, thyroxine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | AST (U/L) | Alk P (U/L) | Other
| | Cyclophosphamide 100 mg daily for 5 weeks
0 | 0 | | 20 | 180
5 weeks | 0 | 1000 | 550 | 720
6 weeks | 1 week | 730 | 300 | 610 | R = 4.4
8 weeks | 3 weeks | 300 | 90 | 200
12 weeks | 7 weeks | 30 | 20 | 110
Normal Values | | <35 | <30 | <130 | Bilirubin levels remained normal

#### Comment

This patient developed liver test abnormalities without symptoms 5 weeks after starting oral cyclophosphamide. The pattern of serum enzyme elevations was just within the range of hepatocellular injury, but the alkaline phosphatase and GGT levels were somewhat more elevated than typically occurs in viral hepatitis. The timing of onset, hepatocellular pattern of injury and prompt improvement in liver tests upon stopping the medication were all supportive of the diagnosis of idiosyncratic drug induced liver injury due to cyclophosphamide.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cyclophosphamide – Cytoxan®

DRUG CLASS

Antineoplastic Agents, Alkylating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cyclophosphamide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cyclophosphamide | 6055-19-2 | C7-H15-Cl2-N2-O2-P.H2-O | Cyclophosphamide Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 05 November 2017

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; mentions that cyclophosphamide can cause veno-occlusive disease [sinusoidal obstruction syndrome, SOS] with massive necrosis and marked aminotransferase elevations).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 551. (Review of hepatotoxicity of cancer chemotherapeutic agents mentions that cyclophosphamide is an uncommon cause of liver toxicity, but in high doses, often in combination with busulfan or irradiation, can cause sinusoidal obstruction syndrome [SOS]).
Chabner BA, Bertino J, Clearly J, Ortiz T, Lane A, Supko JG, Ryan DP. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1677-730. (Textbook of pharmacology and therapeutics).
Aubrey DA. Massive hepatic necrosis after cyclophosphamide. Br Med J 1970; 16: 588. (61 year old woman with breast cancer developed jaundice 2 months after starting cyclophosphamide [50 mg daily], with progressive hepatic failure and death; autopsy showed massive necrosis; few clinical details given). 5454367
Starzl TE, Putnam CW, Halgrimson CG, Schroter GT, Martineau G, Launois B, Corman JL, et al. Cyclophosphamide and whole organ transplantation in human beings. Surg Gynecol Obstet 1971; 133: 981-91. (Experience in using cyclophosphamide instead of azathioprine as an immunosuppressive agent after renal transplantation; equivalent in efficacy and toxicity). 4940540
Wiggelinkhuizen J, McDonald R, Kaschula RO. Cyclophosphamide in the treatment of childhood nephrotic syndrome. S Afr Med J 1972; 46: 1417-23. (Among 34 children with nephrotic syndrome treated with cyclophosphamide, one developed jaundice but then tolerated restarting therapy; may have been acute hepatitis A instead of drug induced liver injury). 4642675
Walters D, Robinson RG, Dick-Smith JB, Corrigan AB, Webb J. Poor response in two cases of juvenile rheumatoid arthritis to treatment with cyclophosphamide. Med J Aust 1972; 2: 1070. (Two children with juvenile rheumatoid arthritis had no clinical response to cyclophosphamide [3 mg/kg/day for 8-12 months], one developed marked ALT elevations that resolved on stopping and the other hemorrhagic cystitis). 4642424
Gravanis MB, Majmudar BN. Clinicopathologic conference: a case of multiple myeloma followed up for 15 years. South Med J 1976; 69: 233-8. (55 year old man with multiple myeloma treated with cyclophosphamide for 15 years developed ascites and jaundice [bilirubin 4.3 mg/dL, AST 344 U/L, Alk P 5 times ULN], autopsy showing massive replacement of liver by malignant hemangioendothelioma). 1251251
Shulman HM, McDonald GB, Matthews D, Doney KC, Kopecky KJ, Gauvreau JM, Thomas ED. An analysis of hepatic venocclusive disease and centrilobular hepatic degeneration following bone marrow transplantation. Gastroenterology 1980; 79: 1178-91. (Analysis of liver biopsies from 204 patients who had undergone hematopoietic cell transplantation [HCT] for various malignancies, finding SOS in 27 patients, early lesions being centrilobular congestion, hepatocyte degeneration and subintimal edema within small central venules and later lesions fibrous obliteration of central venule lunima and fibrosis; correlated with more aggressive conditioning regimens including those with busulfan). 7002704
Jick H, Walker AM, Porter J. Drug-induced liver disease. J Clin Pharmacol 1981; 21: 359-64. (Among 559 medical inpatients receiving cyclophosphamide, one [77 year old man with sarcoma] developed drug induced liver injury after 3 days of use; patient died of the underlying disease before full recovery). 7276230
Bacon AM, Rosenberg SA. Cyclophosphamide hepatotoxicity in a patient with systemic lupus erythematosus. Ann Intern Med 1982; 97: 62-3. (23 year old woman with systemic lupus developed fever and jaundice 6 weeks after starting cyclophosphamide [bilirubin ~13 mg/dL, AST ~3000 U/L, Alk P ~135 U/L], resolving within 3 months of stopping and recurring 2 weeks after restarting [ALT ~700 U/L]). 7092009
Santos GW, Tutschka PJ, Brookmeyer R, Saral R, Beschorner WE, Bias WB, Braine HG, et al. Marrow transplantation for acute nonlymphocytic leukemia after treatment with busulfan and cyclophosphamide. N Engl J Med 1983; 309: 1347-53. (Pilot study of HCT for nonlymphocytic leukemia using conditioning regimen of cyclophosphamide and busulfan; SOS occurred in only 3 patients which was considered lower than occurs with busulfan alone or with total body irradiation combined with cyclophosphamide). 6355849
McDonald GB, Tirumali N. Intestinal and liver toxicity of antineoplastic drugs. West J Med 1984; 140: 250-9. (Review of liver toxicity of anticancer agents; cyclophosphamide has been associated with SOS and with rare cases of acute hepatocellular injury). 6375139
McDonald GB, Sharma P, Matthews DE, Shulman HM, Thomas ED. Venocclusive disease of the liver after bone marrow transplantation: diagnosis, incidence, and predisposing factors. Hepatology 1984; 4: 116-22. (Among 255 patients undergoing hematopoietic cell transplantation [HCT], 53 [21%] met criteria for SOS; risk factors were older age, prior liver disease and AST levels and diagnosis). 6363247
McDonald GB, Sharma P, Matthews DE, Shulman HM, Thomas ED. The clinical course of 53 patients with venocclusive disease of the liver after marrow transplantation. Transplantation 1985; 39: 603-8. (Among 255 patients undergoing HCT for malignant disease, 53 [21%] developed SOS, marked by weight gain [93%] starting ~6 days after transplant followed by jaundice [98%: bilirubin 3.6-29.4 mg/dL], abdominal pain [75%], liver enlargement [68%]; 24 [45%] had serious progressive disease with ascites and hepatic encephalopathy and 17 [32%] died). 3890288
Goldberg JW, Lidsky MD. Cyclophosphamide-associated hepatotoxicity. South Med J. 1985; 78: 222-3. (Case reports of two episodes of hepatic dysfunction associated with oral cyclophosphamide administration in patients with systemic rheumatic diseases). 3975725
Jones RJ, Lee KS, Beschorner WE, Vogel VG, Grochow LB, Braine HG, Vogelsang GB, et al. Veno-occlusive disease of the liver following bone marrow transplantation. Transplantation 1987; 4: 778-83. (Among 235 patients undergoing HCT between 1982 and 1985, SOS developed in 52 [22%] half of whom died, making SOS the third most common cause of death in this population; rare with cyclophosphamide without total body irradiation). 3321587
Shaunak S, Munro JM, Weinbren K, Walport MJ, Cox TM. Cyclophosphamide induced liver necrosis: A possible interaction with azathioprine. Q J Med 1988; 67: 309-17. (4 patients who developed liver injury 2-5 weeks after starting cyclophosphamide [bilirubin 0.8, 1.0, 17.1 and 64 mg/dL, ALT 1842, >600, 556 and >600 U/L, Alk P 303, >450, >414 and 750 U/L], resolving within 1-3 months of stopping; all cases received azathioprine immediately before cyclophosphamide). 3060893
Brodsky R, Topolsky D, Crilley P, Bulova S, Brodsky I. Frequency of veno-occlusive disease of the liver in bone marrow transplantation with a modified busulfan/ cyclophosphamide preparative regimen. Am J Clin Oncol 1990; 13: 221-5. (Among 74 patients undergoing HCT after busulfan and cyclophosphamide conditioning, only 7 [9%] developed SOS, occurrence appeared to correlate with total cyclophosphamide dose). 2346127
Fraiser LH, Kanekal S, Kehrer JP. Cyclophosphamide toxicity: characterizing and avoiding the problem. Drugs 1991; 42: 781-95. (Review of side effects of cyclophosphamide and their prevention and management; no discussion of hepatotoxicity). 1723374
Arai N, Kaneko H, Umeda M, Tsukahara T, Shirai T. [Non-Hodgkin's lymphoma in an elderly patient complicated by cyclophosphamide-induced allergic hepatic dysfunction]. Nippon Ronen Igakkai Zasshi 1992; 29: 681-5. Japanese. (77 year old man developed acute hepatic failure after 3 courses of chemotherapy for lymphoma; lymphocyte stimulation tests suggested that cyclophosphamide was the cause, but multiple agents were used). 1434065
Cleland BD, Pokorny CS. Cyclophosphamide related hepatotoxicity. Aust N Z J Med 1993; 23: 408. (36 year old woman with systemic lupus developed jaundice 2 months after starting 100 mg of cyclophosphamide daily [bilirubin 9.2 mg/dL, ALT 2515 U/L, Alk P 456 U/L, INR normal, eosinophils 14%], resolving in 4 weeks upon stopping: Case 2). 8240157
Snyder LS, Heigh RI, Anderson ML. Cyclophosphamide induced hepatotoxicity in a patient with Wegener's granulomatosis. Mayo Clin Proc 1993; 68: 1203-4. (67 year old woman with Wegener's granulomatosis developed asymptomatic serum enzyme elevations 5 weeks after starting 100 mg of cyclophosphamide daily [normal bilirubin, ALT ~1000 U/L, and Alk P 725 U/L], resolving within 7 weeks of stopping: Case 3). 8246624
Du LT, Rigaud D, Papo T, Godeau P. Cyclophosphamide-induced hepatitis in Wegener's granulomatosis. Mayo Clin Proc 1994; 69: 912-3. (Among 65 patients with Wegener's granulomatosis treated with cyclophosphamide, 1 developed ALT elevations 5 weeks after starting treatment [bilirubin normal; peak ALT 32 times ULN], returning to normal within 2 weeks of stopping and not recurring on azathioprine). 8065199
Modzelewski JR Jr, Daeschner C, Joshi VV, Mullick FG, Ishak KG. Veno-occlusive disease of the liver induced by low-dose cyclophosphamide. Mod Pathol 1994; 7: 967-72. (2 year old female with idiopathic pulmonary hemosiderosis developed progressive liver disease 16 months after starting cyclophosphamide, autopsy showing nodular regeneration and SOS). 7892168
Bearman SI. The syndrome of hepatic veno-occlusive disease after marrow transplantation. Blood 1995; 85: 3005-20. (Review of hepatic SOS after HCT; usually presents with painful hepatomegaly, weight gain [fluid and ascites] and jaundice within 3 weeks of myeloablation with occlusion of central veins and sinusoids and extensive zone 3 [centrolobular] injury). 7756636
Takkal M, Kestens PJ, Noël H, Delos M, Haot J. Hepatic angiosarcoma developed 5 years following treatment for subacute glomerulonephritis. Acta Gastroenterol Belg 1995; 58: 245-51. (Case of liver angiosarcoma which developed following long term treatment with cyclophosphamide). 7571987
Gustafsson LL, Eriksson LS, Dahl ML, Eleborg L, Ericzon BG, Nyberg AN. Cyclophosphamide-induced acute liver failure requiring transplantation in a patient with genetically deficient debrisoquine metabolism: a causal relationship? J Intern Med 1996; 240: 311-4. (58 year old man with rheumatoid arthritis developed acute liver failure 3 months after starting cyclophosphamide and 2 weeks after increasing the dose to 100 mg twice daily [bilirubin 28.6 mg/dL, ALT 2400 U/L, Alk P 1020 U/L, prothrombin index 10%], subsequently developing hepatic failure and undergoing successful liver transplantation; found to be homozygous for poor metabolizing variant of CYP 2D6B). 8946814
Locatelli M, Colleoni M, Noberasco C, Nolé F, Orlando L, Munzone E, Peruzzotti G, et al. Hepatic toxicity from cyclophosphamide, methotrexate, fluorouracil (CMF regimen). Ann Oncol 1999; 10: 1394-5. (Retrospective analysis of liver toxicity of combination anticancer regimen of cyclophosphamide, methotrexate and fluorouracil in 264 patients with breast cancer, 39% had ALT elevations, but all resolved within 30 days, peak bilirubin 1.5 mg/dL; attributed most of injury to methotrexate). 10631475
Mok CC, Wong WM, Shek TW, Ho CT-K, Lau C-S, Lai C-L. Cumulative hepatotoxicity induced by continuous low-dose cyclophosphamide therapy. Am J Gastroenterol 2000; 95: 845-6. (67 year old man with Sjögren syndrome developed jaundice 2 years after starting cyclophosphamide [bilirubin 29.6 mg/dL, ALT 269 U/L, Alk P 213 U/L, no eosinophilia], with biopsy showing cholestatic hepatitis and resolving within 6 weeks of stopping). 10710110
Rosenthal AK, Klausmeier M, Cronin ME, McLaughlin JK. Hepatic angiosarcoma occurring after cyclophosphamide therapy: case report and review of the literature. Am J Clin Oncol 2000; 23: 581-3. (54 year old man with polyarteritis nodosa on oral cyclophosphamide for 13 years developed hepatic angiosarcoma). 11202801
McDonald GB, Slattery JT, Bouvier ME, Ren S, Batchelder AL, Kalhorn TF, Schoch HG, et al. Cyclophosphamide metabolism, liver toxicity, and mortality following hematopoietic stem cell transplantation. Blood 2003; 101: 2043-8. (Among 147 patients who received cyclophosphamide and total body irradiation in preparation of HCT, 23 [16%] developed moderate or severe SOS; rates correlated with higher levels of drug metabolite suggesting that it was the toxic metabolite responsible). 12406916
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but no case was attributed to an antineoplastic agent, perhaps because patients with cancer requiring therapy would rarely be eligible for liver transplantation). 15390328
Muratori L, Ferrari R, Muratori P, Granito A, Bianchi FB. Acute icteric hepatitis induced by a short course of low-dose cyclophosphamide in a patient with lupus nephritis. Dig Dis Sci 2005; 50: 2364-5. (48 year old woman with lupus nephritis developed jaundice 10 days after starting 100 mg of cyclophosphamide daily [bilirubin 11.3 mg/dL, ALT 4222 U/L, Alk P 364 U/L], resolving within 2 months of stopping; gave a history of similar episode after cyclophosphamide therapy in the past). 16416192
McDonald GB, McCune JS, Batchelder A, Cole S, Phillips B, Ren AG, Vicini P, et al. Metabolism-based cyclophosphamide dosing for hematopoietic cell transplant. Clin Pharmacol Ther 2005; 78: 298-308. (Analysis of drug levels of cyclophosphamide during dosing in 20 patients undergoing conditioning for HCT focusing on achieving a target level and adjusting dosage to avoid toxicity and SOS). 16153400
Akay H, Akay T, Secilmis S, Kocak Z, Donderici O. Hepatotoxicity after low-dose cyclophosphamide therapy. South Med J 2006; 99: 1399-400. (40 year old man with scleroderma developed jaundice 6 weeks after starting cyclophosphamide [bilirubin 10.5 mg/dL, ALT 2407 U/L, Alk P 206 U/L], resolving within 11 weeks of stopping: Case 1). 17233202
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports; among 21 drugs with more than 50 cases, four antineoplastic agents were listed: flutamide [59], cyclophosphamide [56], methotrexate [55] and cytarabine [53]) . 16054882
McCune JS, Batchelder A, Deeg HJ, Gooley T, Cole S, Phillips B, Schoch HG, et al. Cyclophosphamide following targeted oral busulfan as conditioning for hematopoietic cell transplantation: pharmacokinetics, liver toxicity, and mortality. Biol Blood Marrow Transplant 2007; 13: 853-62. (Cyclophosphamide pharmacokinetics were determined in 222 patients receiving cyclophosphamide and either busulfan or total body irradiation in preparation of HCT; there was considerable variability in cyclophosphamide levels, being higher in busulfan regimens with modest correlation with SOS). 17580264
Gekkurt E, Stoehlmacher J, Stueber C, Wolschke C, Eiermann T, Iacobelli S, Zander AR, et al. Pharmacogenetic analysis of liver toxicity after busulfan/cyclophosphamide-based allogeneic hematopoietic stem cell transplantation. Anticancer Res 2007; 27: 4377-80. (Retrospective analysis of methylene-tetrahydrofolate-reductase [MTHFR] and glutathione S-transferase [GST] polymorphisms among 84 adults receiving busulfan and cyclophosphamide in preparation for HCT found weak association between a MTHFR polymorphism and SOS [86% rate in those who were homozygous compared to 39% of those who were heterozygous or wild type]). 18214047
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, antineoplastic agents were rarely implicated: 3 were considered due to mercaptopurine and 1 each due to bortezombin, cyclophosphamide, docetaxel, and temozolomide). 18955056
Ulrickson M, Aldridge J, Kim HT, Hochberg EP, Hammerman P, Dube C, Attar E, Ballen KK, Dey BR, McAfee SL, Spitzer TR, Chen YB. Busulfan and cyclophosphamide (Bu/Cy) as a preparative regimen for autologous stem cell transplantation in patients with non-Hodgkin lymphoma: a single-institution experience. Biol Blood Marrow Transplant 2009; 15: 1447-54. (Among 78 patients with non-Hodgkin’s lymphoma undergoing autologous HCT after conditioning with busulfan and cyclosphosphamide, 3 [4%] developed SOS, none fatal). 19822305
Patel A, Patel A, Patel S, Jalandhara P, Thakor P. Cyclophosphamide therapy in granulomatous hepatitis: cure or culprit? Am J Ther 2009; 16: 367-70. (84 year old woman developed fatigue and anorexia 7 weeks after starting oral cyclophosphamide for suspected Wegener's granulomatosis [peak ALT 1002 U/L, Alk P 330 U/L, bilirubin not given], which decreased on stopping cyclophosphamide but recurred on restarting [peak ALT 2025, Alk P 345 U/L], leading to hepatic failure and death). 19262358
McDonald GB. Hepatobiliary complications of hematopoietic cell transplantation, 40 years on. Hepatology 2010; 51: 1450-60. (Review of liver complications of HCT, which have become less frequent with better understanding of their cause and means of prevention; the rate of SOS has decreased because of avoidance of more aggressive ablative therapies [total body irradiation and high dose cyclophosphamide] and better understanding of pharmacokinetics of cyclophosphamide). 20373370
Martínez-Gabarrón M, Enríquez R, Sirvent AE, García-Sepulcre M, Millán I, Amorós F. Hepatotoxicity following cyclophosphamide treatment in a patient with MPO-ANCA vasculitis. Nefrologia 2011; 31: 496-8. (57 year old man with new onset of Wegener granulomatosis developed abdominal pain and ALT elevations within 1 to 4 days of starting each of three courses of cyclophosphamide [ALT 76, 358 and 281 U/L], resolving rapidly but remaining elevated for more than a month after the third episode). 21738257
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but few anticancer drugs were implicated [1 case each for melphalan and gemtuzumab]). 20949552
Cantoni N, Gerull S, Heim D, Halter J, Bucher C, Buser A, Tsakiris DA, et al. Order of application and liver toxicity in patients given BU and CY containing conditioning regimens for allogeneic hematopoietic SCT. Bone Marrow Transplant 2011; 46: 344-9. (Retrospective analysis of liver toxicity after conditioning regimens of busulfan followed by cyclosphospamde versus the reverse order found higher rate of SOS when busulfan was given first [12.5%: 2 of 16 patients] than when it was given after cyclosphosphamide [0 of 59 patients]). 20548339
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 1 case attributed to cyclophosphamide). 23419359
Subramaniam SR, Cader RA, Mohd R, Yen KW, Ghafor HA. Low-dose cyclophosphamide-induced acute hepatotoxicity. Am J Case Rep 2013; 14: 345-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/24023976) (48 year old man with rapidly progressive glomerulonephritis developed marked ALT elevations after intravenous infusions of cyclophosphamide [ALT 41 rising to 568 U/L in 4 days] and higher after a second infusion [1253 U/L], and died of complications of pneumonia shortly thereafter).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/24552865) (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, one of which was attributed to cyclophosphamide).
Douros A, Bronder E, Andersohn F, Klimpel A, Thomae M, Sarganas G, Kreutz R, et al. Drug-induced liver injury: results from the hospital-based Berlin Case-Control Surveillance Study. Br J Clin Pharmacol 2015; 79: 988-99. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25444550) (Among 198 patients with suspected drug induced liver injury enrolled in a case control surveillance study involving 51 hospitals in Berlin between 2002 and 2011, one case was considered probably due to cyclophosphamide).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25754159) (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 cases [6%] were attributed to antineoplastic agents, 2 of which were due to cyclophosphamide).

## OTHER REFERENCE LINKS

1. Recent References on Cyclophosphamide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Cyclophosphamide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cyclophosphamide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cyclophosphamide)